# Efalizumab

## OVERVIEW

### Introduction

Efalizumab is a humanized monoclonal antibody to human CD11a subunit of the lymphocyte function-associated antigen 1, which acts as an immunosuppressant agent blocking lymphocyte activation and was formerly used to treat severe plaque psoriasis. Efalizumab has been linked to rare instances of idiosyncratic acute liver injury and may be a rare cause of reactivation of hepatitis B.

### Background

Efalizumab (ef” al iz’ ue mab) is a recombinant, humanized monoclonal antibody to CD11a, a subunit of the lymphocyte function-associated antigen 1 (LFA-1), which is present on lymphocytes and causes activation and proliferation of lymphocytes. Blocking of CD11a inhibits lymphocyte activation and decreases migration of lymphocytes to sites of inflammation. Efalizumab has been shown to have potent immunosuppressive activity and to lower lymphocyte counts and improve autoimmune conditions. In controlled studies, efalizumab was shown to be effective in inducing clinical responses in 20% to 30% of patients with severe psoriasis. Efalizumab was approved for use in the United States in 2005 as therapy for severe plaque psoriasis, but was withdrawn in 2009 because of several instances of progressive multifocal leukoencephalopathy (PMLE), a severe neurological condition which is believed to be due to reactivation of the JC virus in neural cells. Efalizumab was previously available in 125 mg single use vials under the brand name Raptiva. The recommended initial dose was 0.7 mg/kg subcutaneously, followed by weekly doses of 1 mg/kg, with maximum single dose of 200 mg. Common side effects included headache, fatigue, fever, muscle and back aches, nausea, acne and hypersensitivity reactions. Efalizumab is also capable of causing immune suppression, resulting in an increased susceptibility to opportunistic infections.

### Hepatotoxicity

In large clinical trials of efalizumab, serum alkaline phosphatase levels were often reported to be mildly elevated (by 2-3 U/L) compared to baseline, but serum aminotransferase values did not change and there were no reports of marked ALT elevations or clinically apparent liver injury due to the monoclonal antibody therapy. After its approval and wider scale clinical use, there were several reports of liver injury attributed to efalizumab therapy, one case of apparent reactivation of hepatitis B (with concurrent adalimumab therapy) and one case of a self-perpetuating autoimmune hepatitis, arising after 8 weeks of efalizumab therapy and not resolving with stopping the monoclonal antibody and requiring corticosteroid therapy.

Likelihood score: D (possible rare cause of clinically apparent liver injury, including HBV reactivation).

### Mechanism of Injury

The mechanism of liver injury caused by efalizumab is probably immunologically mediated, perhaps as a result of its effects on leukocyte function in causing an autoimmune reaction or reactivation of hepatitis B. Efalizumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity.

### Outcome and Management

The hepatotoxicity of efalizumab is not well established, but in some instances resembles autoimmune hepatitis and warrants corticosteroid therapy. Other cases of liver injury during efalizumab therapy may represent reactivation of hepatitis B and call for antiviral therapy with drugs active against HBV.

Other immunomodulatory monoclonal antibodies used to treat autoimmune diseases include adalimumab, certolizumab, golimumab, infliximab, natalizumab, rituximab and tocilizumab.

Drug Class: Monoclonal Antibodies; Immunomodulatory Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Efalizumab – Raptiva®

DRUG CLASS

Immunomodulatory Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Efalizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Efalizumab | 214745-43-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; efalizumab not specifically mentioned).
Krensky AM, Vincenti F, Bennett WM. Immunomodulators. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 11th ed. New York: McGraw-Hill, 2006, pp. 1405-88. (Textbook of pharmacology and therapeutics).
Efalizumab (Raptiva) for treatment of psoriasis. Med Lett Drugs Ther 2003; 45 (1171): 97-8. (Concise summary of efficacy, safety and costs of efalizumab shortly after its approval for use in psoriasis in the US; no mention of ALT elevations or hepatotoxicity). 14657802
Lebwohl M, Tyring SK, Hamilton TK, Toth D, Glazer S, Tawfik NH, Walicke P, et al.; Efalizumab Study Group. A novel targeted T-cell modulator, efalizumab, for plaque psoriasis. N Engl J Med 2003; 349: 004-13. (Among 597 patients with psoriasis treated with efalizumab [1 or 2 mg/kg/week] or placebo for 12-24 weeks, clinical responses were more frequent with efalizumab [22% and 28% vs 5% at week 12] as were side effects including headaches, chills, fever, nausea, myalgias, and acne; Alk P and GGT levels were slightly and transiently elevated, but there were “no other notable changes” in laboratory values). 14627785
Dubertret L, Sterry W, Bos JD, Chimenti S, Shumack S, Larsen CG, Shear NH, Papp KA; CLEAR Multinational Study Group. Clinical experience acquired with the efalizumab (Raptiva) (CLEAR) trial in patients with moderate-to-severe plaque psoriasis: results from a phase III international randomized, placebo-controlled trial. Br J Dermatol 2006; 155: 170-81. (Among 793 patients with psoriasis treated with efalizumab or placebo for 12 weeks, Alk P levels increased by ~3 U/L by week 12, but abnormalities of ALT and AST "were generally similar to those present at baseline"). 16792770
Papp KA, Bressinck R, Fretzin S, Goffe B, Kempers S, Gordon KB, Caro I, et al.; Efalizumab Study Group. Safety of efalizumab in adults with chronic moderate to severe plaque psoriasis: a phase IIIb, randomized, controlled trial. Int J Dermatol 2006; 45: 605-14. (Among 686 patients with psoriasis who received efalizumab [0.7 mg/kg initially and then 1 mg/kg weekly] or placebo for 12 weeks, there were "no clinically significant changes in... laboratory parameters and no evidence of end-organ toxicities"; there was a slight increase in Alk P levels but no change in ALT or AST values). 16700803
Gordon KB, Papp KA, Hamilton TK, Walicke PA, Dummer W, Li N, Bresnahan BW, Menter A; Efalizumab Study Group. Efalizumab for patients with moderate to severe plaque psoriasis: a randomized controlled trial. JAMA 2003; 290: 3073-80. (Among 556 patients with psoriasis treated with efalizumab or placebo for 12 weeks, response rates were 24% on efalizumab vs 4% of placebo, and therapy was "safe and well tolerated" with "no clinically significant laboratory abnormalities"). 14679270
Kaiser T, Moessner J, Patel K, McHutchison JG, Tillmann HL. Life threatening liver disease during treatment with monoclonal antibodies. BMJ 2009; 338: b508. (66 year old man with psoriasis was treated with efalizumab [anti-CD11a] and then adalimumab [anti-TNF], and 11 days later developed jaundice and severe hepatitis [bilirubin 9.1 rising to 52 mg/dL, ALT 549 U/L, Alk P 131 U/L], with HBsAg being detected and slow but eventual recovery). 19224957
Primo J, Michavila J, Jiménez I. [Efalizumab-induced autoimmune hepatitis]. Gastroenterol Hepatol 2010 Jan; 33 (1): 69-70. Spanish. (55 year old woman with psoriasis developed serum enzyme elevations after 9 doses of efalizumab [50 mg weekly], with bilirubin normal, but ALT 235 U/L, Alk P 428 U/L, ANA rising to 1:1,280 which persisted for 6 months despite stopping therapy, ultimately responding to corticosteroid and azathioprine therapy). 19800148
Gadzia J, Turner J. Progressive multifocal leukoencephalopathy in two psoriasis patients treated with efalizumab. J Drugs Dermatol 2010; 9: 1005-9. (Two patients, 70 and 73 year old, man and woman, treated for psoriasis with efalizumab for more than 3 years developed progressive neurologic deficits and had JC virus found in spinal fluid compatible with diagnosis of progressive multifocal leukoencephalopathy [PMLE], dying shortly after diagnosis). 20684152
Kothary N, Diak IL, Brinker A, Bezabeh S, Avigan M, Dal Pan G. Progressive multifocal leukoencephalopathy associated with efalizumab use in psoriasis patients. J Am Acad Dermatol 2011; 65: 546-51. (Analysis of 3 cases of PMLE associated with efalizumab therapy of psoriasis from the FDA Adverse Event Reporting System, 2 men and 1 woman, ages 43-73 on efalizumab for 3 to 4 years, presenting with vertigo, ataxia, paraesthesias and progressive neurologic course, dying 2-6 months after presentation). 21514689
Aithal GP. Hepatotoxicity related to antirheumatic drugs. Nat Rev Rheumatol 2011; 7: 139-50. (Analysis of spontaneous adverse event reporting of progressive PMLE in the US between 2004-2010 identified 635 cases with higher than expected number of cases from several immunosuppressive monoclonal antibodies, including efalizumab [n=12], rituximab [124] and natalizumab [123]). 17723920
Rustin MH. Long-term safety of biologics in the treatment of moderate-to-severe plaque psoriasis: review of current data. Br J Dermatol 2012; 167 Suppl 3: 3-11. (Analysis of long term severe adverse events associated with use of biologic agents for psoriasis: "with the exception of efalizumab,..., these biologics are generally well tolerated in long-term studies"). 23082810
Badavanis G, Pasmatzi E, Monastirli A, Tsambaos D. Biologic agents in systemic dermatotherapy: cutaneous and systemic side effects. Curr Drug Saf 2017 May 18. [Epub ahead of print] (Review of the systemic side effects of biologic agents used to treat psoriasis after the withdrawal of efalizumab because of a concern over its serious and fatal side effects). 28521707

## OTHER REFERENCE LINKS

1. Recent References on Efalizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Efalizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Efalizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Efalizumab)